# Fosamprenavir

## OVERVIEW

### Introduction

Amprenavir is an antiretroviral protease inhibitor used in the therapy and prevention of human immunodeficiency virus (HIV) infection and the acquired immunodeficiency syndrome (AIDS). Fosamprenavir is a prodrug of amprenavir that has better oral bioavailability and that has largely replaced amprenavir in clinical use. Both amprenavir and fosamprenavir can cause transient and usually asymptomatic elevations in serum aminotransferase levels and are rare causes of clinically apparent, acute liver injury. In coinfected patients, hepatic injury during highly active antiretroviral therapy may be a result of exacerbation of the underlying chronic hepatitis B or C rather than a direct toxic effect of the medication.

### Background

Amprenavir (am pren' a vir) is sulfonamide nonpeptide HIV protease inhibitor that acts by binding to the catalytic site of the viral protease, thereby preventing the cleavage of HIV polyprotein precursors into mature, functional proteins that are necessary for viral replication. Fosamprenavir (fos" am pren' a vir) is a phosphonooxy prodrug of amprenavir which is more water soluble and has greater bioavailability than amprenavir. Fosamprenavir is rapidly converted to amprenavir in the intestinal mucosa. Amprenavir was approved for use in the United States in 1999 and fosamprenavir in 2003 for the therapy of HIV infection in adults and children in combination with other antiretroviral agents. Amprenavir was previously available in capsules of 50 mg under the brand name Agenerase. The pill burden of amprenavir therapy made fosamprenavir preferable and amprenavir is no longer availble in the United States. Fosamprenavir is available in tablets of 700 mg and in a liquid solution for pediatric use (50 mg/mL) under the brand name Lexiva. Both agents are typically used in combination with low "booster" doses of ritonavir (100 or 200 mg daily). The recommended dose of fosamprenavir is 1400 mg twice daily when given without ritonavir or 1400 mg once daily when given with ritonavir. The dose in children is weight based. Common side effects include diarrhea, nausea, gastrointestinal upset, headache, fatigue and, with long term use, hyperlipidemia and lipodystrophy.

### Hepatotoxicity

Some degree of serum aminotransferase elevations occur in a high proportion of patients taking amprenavir or fosamprenavir containing antiretroviral regimens. In large, multicenter trials of fosamprenavir based antiretroviral therapy, moderate-to-severe elevations in serum aminotransferase levels (>5 times the upper limit of normal) were found in 3% to 10% of patients. Rates of enzyme elevations are higher in patients with HIV-HCV coinfection then in those with monoinfection. These elevations are usually asymptomatic and self-limited and can resolve even with continuation of the medication. Furthermore, similar rates of enzyme elevations were found in comparator arms (using other HIV protease inhibitors).

Clinically apparent acute liver injury due to amprenavir or fosamprenavir is rare and the specific clinical features have not been characterized in any detail. The few cases of symptomatic liver injury that have been reported have arisen after 1 to 8 weeks of starting the agent, and the pattern of serum enzyme elevations has not been well defined, but probably largely hepatocellular (Cases 1 and 2). Signs of hypersensitivity (fever, rash, eosinophilia) can occur, but autoantibody formation is rare. The acute liver injury due to HIV protease therapy is usually self-limited, but it can be severe, and isolated cases of acute liver failure have been reported with some agents. In HBV or HCV coinfected patients, acute liver injury may be caused by an exacerbation of the underlying chronic liver disease, perhaps as a result of sudden immune reconstitution. Neither amprenavir nor fosamprenavir have been clearly linked to lactic acidosis and acute fatty liver that is reported in association with several nucleoside analogue reverse transcriptase inhibitors.

Likelihood score: D (possible rare cause of clinically apparent liver injury)

### Mechanism of Injury

The cause of the clinical hepatotoxicity from amprenavir or fosamprenavir is not well understood. Amprenavir is extensively metabolized by the liver, largely by the cytochrome P450 system (CYP 3A4), and toxic or immunogenic intermediates may be the cause of some liver injury. Clinically apparent cases of liver injury have had many features of hypersensitivity. In patients with HIV infection who are coinfected with either HBV or HCV, initiation of potent antiretroviral therapy may be associated with flares of the underlying chronic hepatitis which may be the result of reconstitution of the immune system, viral interactions or a direct effect of the drug.

### Outcome and Management

The severity of the liver injury from amprenavir or fosamprenavir ranges from mild and transient enzyme elevations to more marked and symptomatic enzyme elevations and, rarely, to acute hepatitis which is usually self-limited. Typically, improvements start within a few days of stopping therapy and recovery is usually rapid. Rechallenge with either or switching from one to the other is likely to lead to recurrence and should be avoided. There is little evidence for cross reactivity to the hepatotoxicity of amprenavir and fosamprenavir with other HIV protease inhibitors.

References to amprenavir and fosprenavir are included with references to all the HIV protease inhibitors in the Overview section of Protease Inhibitors (updated September 2017). Most of the HIV protease inhibitors in clinical use are proteinomimetic drugs and are structurally unrelated.

Drug Class: Antiviral Agents, Antiretroviral Agents

Other Drugs in the Subclass, Protease Inhibitors: Atazanavir, Darunavir, Indinavir, Lopinavir, Nelfinavir, Ritonavir, Saquinavir, Tipranavir

## CASE REPORTS

### Case 1. Liver injury during fosamprenavir therapy for post exposure prophylaxis.

[Modified from: Pavel S, Burty C, Alcaraz I, de la Tribonnière X, Baclet V, Ajana F, Mouton Y, et al. Severe liver toxicity in postexposure prophylaxis for HIV infection with a zidovudine, lamivudine and fosamprenavir/ritonavir regimen. AIDS 2007; 21: 268-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/17197833)]

A 22 year old woman with an acute exposure to an individual suspected to have HIV and HCV developed nausea and abdominal pain 8 days after starting a prophylactic regimen of lamivudine, zidovudine and fosamprenavir/ritonavir. Blood tests taken one week later showed ALT of 517 U/L without HCV RNA or HIV viremia. She had received HBV vaccine and was anti-HBs positive. The antiretroviral agents were stopped and serum aminotransferase levels were normal 2 weeks later. She remained free of both HCV and HIV infection.

#### Key Points

Medication: | Fosamprenavir
Pattern: | Unknown, no alkaline phosphatase or bilirubin levels given
Severity: | 1+
Latency: | 8 days to symptoms, 15 days to ALT elevations
Recovery: | 2 weeks
Other medications: | Hormonal contraceptive agents, vibramycin

#### Comment

Scant information is provided, but the patient appeared to have elevations in serum aminotransferase levels two weeks after starting combination antiretroviral therapy, including fosamprenavir with low dose ritonavir. This regimen is also associated with gastrointestinal symptoms (abdominal pain and nausea) independent of hepatic injury and it is not clear whether the symptoms and the ALT elevations were related. Interestingly, this regimen was not associated with high rates of hepatotoxicity in clinical trials and other case series, but has been associated with precipitation of hepatic decompensation in patients with cirrhosis due to hepatitis C.

### Case 2. Liver toxicity after post exposure prophylaxis with fosamprenavir in 29 year old male.

[Modified from: Pavel S, Burty C, Alcaraz I, de la Tribonnière X, Baclet V, Ajana F, Mouton Y, et al. Severe liver toxicity in postexposure prophylaxis for HIV infection with a zidovudine, lamivudine and fosamprenavir/ritonavir regimen. AIDS 2007; 21: 268-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/17197833)]

A 29 year old man, undergoing postexposure prophylaxis after a sexual exposure to HIV, developed a generalized maculopapular rash after 9 days of therapy with lamivudine, zidovudine and fosamprenavir/ritonavir. Physical examination suggested the diagnosis of erythema multiforme. Serum ALT was 958 U/L, but neither HCV RNA nor HIV viremia were detected. Both HBsAg and anti-HBc were also negative. The antiretrovirals were stopped. He improved and six weeks later the rash was gone and serum aminotransferase levels were normal.

#### Key Points

Medication: | Fosamprenavir
Pattern: | Unknown, no alkaline phosphatase or bilirubin levels given
Severity: | 1+
Latency: | 9 days
Recovery: | 6 weeks
Other medications: | Lamivudine, zidovudine

#### Comment

Another case from the same investigators with few details of the nature and course of the hepatic injury (no bilirubin, alkaline phosphatase or INR results). The patient appeared to develop an acute hypersensitivity reaction after 9 days of an antiretroviral regimen that included fosamprenavir and low dose ritonavir (as well as lamivudine and zidovudine). Acute hypersensitivity reactions due to medications with rash, fever and eosinophilia are frequently accompanied by evidence of hepatitis, sometimes with symptoms and jaundice, but more frequently with serum aminotransferase elevations without hyperbilirubinemia.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Amprenavir – Agenerase®

Fosamprenavir – Lexiva®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=amprenavir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Amprenavir | 161814-49-9 | C25-H35-N3-O6-S | Amprenavir Chemical Structure
Fosamprenavir | 226700-79-4 | C25-H36-N3-O9-P-S | Fosamprenavir Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Amprenavir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Amprenavir%20/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Amprenavir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Amprenavir)